# Daclatasvir

## OVERVIEW

### Introduction

Daclatasvir is an orally available antiviral agent that inhibits the NS5A region of the hepatitis C virus (HCV) and was used in combination with other oral antiviral agents to treat chronic hepatitis C before its withdrawal in 2019. Elevations in serum enzyme levels during daclatasvir therapy are uncommon, and it has yet to be convincingly implicated in cases of idiosyncratic liver injury with jaundice. Nevertheless, successful all-oral regimens of antiviral therapy in patients with chronic hepatitis C and cirrhosis is occasionally complicated by hepatic decompensation and may cause reactivation of hepatitis B in susceptible patients coinfected with the hepatitis B virus (HBV).

### Background

The hepatitis C virus is a small RNA virus that is a major cause of chronic hepatitis, cirrhosis and hepatocellular carcinoma in the United States as well as worldwide. Various approaches to antiviral therapy of chronic hepatitis C have been developed, starting in the 1980s with interferon alfa, which was replaced in the 1990s by long acting forms of interferon (peginterferon) to which was added the oral nucleoside analogue, ribavirin. Between 2010 and 2015, several potent oral, direct acting anti-HCV agents were developed and combinations of these found to have marked activity against the virus, allowing for highly effective therapy without use of interferon, with excellent tolerance and safety and treatment courses of 8, 12 or 24 weeks only. These direct acting agents included HCV protease (NS3/4) inhibitors, structural replication complex (NS5A) inhibitors and the HCV RNA polymerase (NS5B) inhibitors.

Daclatasvir (dak lat' as vir) is an oral antiviral agent with specific activity against the NS5A region of the hepatitis C virus. The role of the NS5A region and how daclatasvir inhibits its function are not well defined, but NS5A is necessary for formation of the replicative complex of HCV and the various NS5A inhibitors, such as daclatasvir, appear to bind to this polypeptide and prevent its participation in forming the intracellular complex that is necessary for HCV replication. In cell culture and in animal models, daclatasvir caused a rapid and marked decrease in viral replication and HCV RNA levels. In several prospective, placebo controlled trials, daclatasvir in combination with other antiviral agents (such as sofosbuvir, asunaprevir, peginterferon and ribavirin) was found to decrease HCV RNA levels and lead to sustained loss of HCV RNA in a high proportion of patients with chronic hepatitis C. Daclatasvir was approved for use in combination with other antiviral agents as therapy of chronic hepatitis C in the United States in 2015. Because of the availability of other potent HCV NS5A inhibitors combined in fixed doses with sofosbuvir (Harvoni, Epclusa) or HCV protease inhibitors (Mavyret), daclatasvir was withdrawn by the sponsor in 2019. Daclatasvir was available in the United States as tablets of 30 and 60 mg under the brand name Daklinza between 2015 and 2019. The recommended dose in adults was one capsule (60 mg) orally once daily in combination with sofosbuvir (400 mg daily) for 12 weeks. Initial indications were limited to patients with HCV genotype 3, although several studies have shown that it is also active against other HCV genotypes. Side effects were uncommon, but were generally mild and included headache, fatigue and nausea.

### Hepatotoxicity

In large randomized controlled trials, daclatasvir was not associated with serum enzyme elevations during therapy. A difficulty in assessing side effects of daclatasvir and other anti-HCV agents, however, was that they are never used as monotherapy, but were also combined with agents active against other HCV targets, such as the viral protease (NS3) or polymerase (NS5B). Daclatasvir was also commonly used in combination with the more traditional agents used for hepatitis C, such as peginterferon and ribavirin, both of which have prominent adverse effects. In combination with asunaprevir (an HCV protease inhibitor), daclatasvir was associated with serum ALT elevations in 3% to 11% of patients and with several instances of acute hypersensitivity and hepatitis, some of which were severe. The cause of the hypersensitivity reaction, however, appeared to be asunaprevir. In combination with sofosbuvir, daclatasvir was not associated with serum enzyme elevations or with clinically apparent liver injury.

Daclatasvir has, however, been implicated in rare instances of acute decompensation of HCV related cirrhosis. The role of daclatasvir and the other HCV antivirals in this syndrome, however, was unclear. The liver injury usually arose within 2 to 6 weeks of starting therapy, but occasionally later and even after discontinuation of therapy. The injury was marked by worsening jaundice and signs of hepatic failure. In some instances, lactic acidosis was present early. In most but not all instances, the serum enzymes increased minimally if at all, despite the worsening hepatic failure. Several instances resulted in death or need for emergency liver transplantation. For this reason, it was recommended that patients with cirrhosis undergoing antiviral therapy with potent direct acting agents should be monitored carefully, particularly during the first few weeks of treatment.

Finally, reactivation of hepatitis B has occurred in rare patients being treated for chronic hepatitis C some of whom had received daclatasvir. The relationship of HBV reactivation to the antiviral treatment of HCV infection is not clear, but it may be due to clearance of HCV replication which allows HBV DNA levels to increase.

Likelihood score: C (probable rare cause of clinically apparent liver injury in patients with cirrhosis or preexisting hepatitis B virus coinfection).

### Mechanism of Injury

The mechanism by which daclatasvir might cause liver injury is not known. It is metabolized in the liver largely via the cytochrome P450 system, predominantly CYP 3A4 and liver injury may be due to production of a toxic or immunogenic metabolite. Daclatasvir is also susceptible to drug-drug interactions with strong CYP 3A4 inducers (such as efavirenz or rifampin) or inhibitors (such as ketoconazole).

### Outcome and Management

Daclatasvir in combination with other potent direct acting agents for hepatitis C (such as sofosbuvir) has been associated with instances of hepatic decompensation in patients with preexisting cirrhosis. For these reasons, monitoring of liver tests is recommended, particularly during the first 4 weeks of therapy. Treatment should be interrupted with jaundice and signs of hepatic decompensation arise. All patients who are to receive antiviral therapy for hepatitis C should be screened for presence of hepatitis B surface antigen (HBsAg) and antibody to hepatitis B core antigen (anti-HBc). Those who are reactive for the HBV markers should be monitored for evidence of reactivation during antiviral therapy of hepatitis C with serial testing for HBV DNA and started on therapy for hepatitis B if HBV DNA levels appear de novo or rise significantly.

Drug Class: Antiviral Agents, Hepatitis C Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Daclatasvir – Daklinza®

DRUG CLASS

Hepatitis C Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Daclatasvir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Daclatasvir | 1009119-64-5 | C40-H50-N8-O6

## ANNOTATED BIBLIOGRAPHY

References updated: 07 February 2022

Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss oral, direct acting antiviral agents used to treat hepatitis C).
Lemm JA, Leet JE, O'Boyle DR, Romine JL, Huang XS, Schroeder DR, Alberts J, et al. (2011). Discovery of potent hepatitis C virus NS5A inhibitors with dimeric structures. Antimicrob Agents Chemother. (High throughput screening of molecules for activity in a HCV replicon system identified a thiazolidinone NS5A inhibitor that was characterized as a dimer molecule, a derivative of which was synthesized leading to the identification of a stable, active agent, BMS-790052 [daclatasvir], which was then shown to have excellent clinical activity).
Lok AS, Gardiner DF, Lawitz E, Martorell C, Everson GT, Ghalib R, Reindollar R, et al. (2012). Preliminary study of two antiviral agents for hepatitis C genotype 1. N Engl J Med. (Among 21 previously treated patients with chronic hepatitis C, genotype 1, who received daclatasvir and asunaprevir with or without peginterferon and ribavirin, 4 of 9 [44%] who received the oral antiviral agents alone had an SVR and 6 of the 21 had transient ALT elevations above 3 times ULN [peak: 370 U/L], but all resolved and none were associated with jaundice).
Pol S, Ghalib RH, Rustgi VK, Martorell C, Everson GT, Tatum HA, Hézode C, et al. (2012). Daclatasvirr for previously untreated chronic hepatitis C genotype-1 infection: a randomised, parallel-group, double-blind, placebo-controlled, dose-finding, phase 2a trial. Lancet Infect Dis. (Among 48 patients treated with peginterferon and ribavirin in combination with placebo or one of 3 doses of daclatasvir for 48 weeks, SVR rates were higher with daclatasvir [42% to 92%] than placebo [25%] and adverse events were similar in all groups).
Sheridan C. (2012). Calamitous HCV trial casts shadow over nucleoside drugs. Nat Biotechnol. (News report on cases of cardiotoxicity associated with an HCV RNA polymerase inhibitor [BMS 986094; a pro-drug of 6-O-methyl-2’-C-methylguanosine] combined with daclatasvir).
Suzuki Y, Ikeda K, Suzuki F, Toyota J, Karino Y, Chayama K, Kawakami Y, et al. (2013). Dual oral therapy with daclatasvir and asunaprevir for patients with HCV genotype 1b infection and limited treatment options. J Hepatol. (Among 43 patients with chronic hepatitis C, genotype 1b, treated with daclatasvir and asunaprevir alone for 24 weeks, 77% had an SVR; 12 patients had ALT elevations, 2 of whom developed jaundice, but the liver injury resolved in all, although 4 required early discontinuation).
Everson GT, Sims KD, Rodriguez-Torres M, Hézode C, Lawitz E, Bourlière M, Loustaud-Ratti V, et al. (2014). Efficacy of an interferon- and ribavirin-free regimen of daclatasvir, asunaprevir, and BMS-791325 in treatment-naive patients with HCV genotype 1 infection. Gastroenterology. (Among 66 patients with chronic hepatitis C, genotype 1, treated with daclatasvir, asunaprevir and a nonnucleoside NS5B inhibitor for 12 or 24 weeks, 61 had an SVR and none had ALT elevations above 5 times ULN).
Sulkowski MS, Gardiner DF, Rodriguez-Torres M, Reddy KR, Hassanein T, Jacobson I, Lawitz E, et al. (2014). AI444040 Study Group. Daclatasvirr plus sofosbuvir for previously treated or untreated chronic HCV infection. N Engl J Med. (Among 211 patients with chronic hepatitis C treated with daclatasvir and sofosbuvir with or without ribavirin for 12 or 24 weeks, SVR rates were 98% for genotype 1, 92% genotype 2 and 89% genotype 3; serious adverse events occurred in 10 patients, but none were liver related, and there was no mention of ALT elevations).
Lok AS, Gardiner DF, Hézode C, Lawitz EJ, Bourlière M, Everson GT, Marcellin P, et al. (2014). Randomized trial of daclatasvir and asunaprevir with or without PegIFN/RBV for hepatitis C virus genotype 1 null responders. J Hepatol. (Among 101 patients with chronic hepatitis C treated with a 24 week course of daclatasvir with various regimens including asunaprevir, peginterferon and ribavirin, 4 patients [4%] had ALT elevations above 5 times ULN [peak: 590 U/L], but none had symptoms or jaundice and all recovered without need of early discontinuation).
Belema M, Nguyen VN, Bachand C, Deon DH, Goodrich JT, James CA, Lavoie R, et al. (2014). Hepatitis C virus NS5A replication complex inhibitors: the discovery of daclatasvir. J Med Chem. (Description of the identification of an inhibitor of the NS5A replication complex and subsequent further refinement of the compound to allow for oral absorption: compound 33, daclatasvir).
Kumada H, Suzuki Y, Ikeda K, Toyota J, Karino Y, Chayama K, Kawakami Y, et al. (2014). Daclatasvirr plus asunaprevir for chronic HCV genotype 1b infection. Hepatology. (Among 222 Japanese patients with chronic hepatitis C, genotype 1, treated with daclatasvir and asunaprevir for 24 weeks, 85% achieved an SVR, while ALT elevations above 5 times ULN occurred in 16 patients [7%], two with concurrent bilirubin elevations, 10 requiring early discontinuation; enzyme elevations arose within 4 to 23 weeks of starting and resolved within 2 to 3 weeks of stopping).
Pellicelli AM, Montalbano M, Lionetti R, Durand C, Ferenci P, D'Offizi G, Knop V, et al. (2014). Sofosbuvir plus daclatasvir for post-transplant recurrent hepatitis C: potent antiviral activity but no clinical benefit if treatment is given late. Dig Liver Dis. (Among 12 patients with severe chronic hepatitis C, genotype 1 and 4, after liver transplantation treated with sofosbuvir and daclatasvir with or without ribavirin for 24 weeks, 3 died of progressive hepatic failure during therapy [weeks 4, 8 and 10] and the other 9 had an SVR).
Manns M, Pol S, Jacobson IM, Marcellin P, Gordon SC, Peng CY, Chang TT, et al., HALLMARK-DUAL Study Team. (2014). All-oral daclatasvir plus asunaprevir for hepatitis C virus genotype 1b: a multinational, phase 3, multicohort study. Lancet. (Among 747 patients with chronic hepatitis C, genotype 1b, treated with daclatasvir and asunaprevir or placebo for 12 or 24 weeks, 21 patients [3%] had ALT elevations above 5 times ULN and 7 [1%] were withdrawn from treatment early because of ALT elevations).
Fujii Y, Uchida Y, Mochida S. (2015). Drug-induced immunoallergic hepatitis during combination therapy with daclatasvir and asunaprevir. Hepatology. (57 year old Japanese man with chronic hepatitis C, genotype 1b, developed fever and eosinophilia at week 2 and jaundice by week 4 of therapy with daclatasvir and asunaprevir [bilirubin 3.3 mg/dL, ALT 609 U/L, Alk P 320 U/L], resolving rapidly with stopping therapy and starting prednisone, HCV relapsing in follow up).
Nelson DR, Cooper JN, Lalezari JP, Lawitz E, Pockros PJ, Gitlin N, Freilich BF, et al., ALLY-3 Study Team. (2015). All-oral 12-week treatment with daclatasvir plus sofosbuvir in patients with hepatitis C virus genotype 3 infection: ALLY-3 phase III study. Hepatology. (Among 152 patients with chronic hepatitis C, genotype 3, treated with sofosbuvir and daclatasvir for 12 weeks, 135 [89%] had an SVR, and there were no treatment related serious adverse events, early discontinuations for adverse events or de novo ALT elevations above 5 times ULN).
Jensen D, Sherman KE, Hézode C, Pol S, Zeuzem S, de Ledinghen V, Tran A, et al., HALLMARK-QUAD Study Team. (2015). Daclatasvirr and asunaprevir plus peginterferon alfa and ribavirin in HCV genotype 1 or 4 non-responders. J Hepatol. (Among 398 previously treated patients with chronic hepatitis C, genotype 1 or 4, treated with daclatasvir, asunaprevir, peginterferon and ribavirin for 24 weeks, SVR rates were 93% and 100%; ALT elevations above 5 times ULN occurred in 12 patients [3%], one with concurrent elevation in bilirubin, arising within 16 to 86 days of starting and resolving within 9 to 85 days).
Cornella SL, Stine JG, Kelly V, Caldwell SH, Shah NL. (2015). Persistence of mixed cryoglobulinemia despite cure of hepatitis C with new oral antiviral therapy including direct-acting antiviral sofosbuvir: A case series. Postgrad Med. (Among 5 patients with chronic hepatitis C and cryoglobulinemia, successful therapy with antiviral regimens resulted in loss of cryoglobulins in only 2 patients, and most had persistence of renal and neurologic symptoms despite clearance of HCV RNA and resolution of liver disease).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were attributed to antiviral agents, but all were antiretroviral agents and no case was attributed to the oral direct acting agents used to treat hepatitis C).
(2015). In brief: severe bradycardia with sofosbuvir and amiodarone. Med Lett Drugs Ther. (Summary of FDA warning regarding life threatening bradycardia in patients on amiodarone therapy who are treated with sofosbuvir, occurring within hours to up to 12 days after starting; 3 patients required pacemakers and one died).
Muir AJ, Poordad F, Lalezari J, Everson G, Dore GJ, Herring R, Sheikh A, et al. (2015). Daclatasvirr in combination with asunaprevir and beclabuvir for hepatitis C virus genotype 1 infection with compensated cirrhosis. JAMA. (Among 202 patients with chronic hepatitis C, genotype 1, and cirrhosis treated with daclatasvir, asunaprevir and beclabuvir with or without ribavirin for 12 weeks, SVR rates were 87% to 98%; ALT elevations above 5 times ULN occurred in 4 patients [2%], one with concurrent bilirubin elevations [bilirubin 2.4 mg/dL, ALT 992 U/L], which resolved within 6 weeks of early discontinuation).
Bunchorntavakul C, Reddy KR. (2015). Review article: the efficacy and safety of daclatasvir in the treatment of chronic hepatitis C virus infection. Aliment Pharmacol Ther. (Review of safety and efficacy of daclatasvir for chronic hepatitis C, mentions that 5% to 29% of patients treated with both daclatasvir and asunaprevir developed significant ALT elevations, but these were most likely due to asunaprevir).
Leroy V, Dumortier J, Coilly A, Sebagh M, Fougerou-Leurent C, Radenne S, Botta D, et al.; Agence Nationale de Recherches sur le SIDA et les Hépatites Virales CO23 Compassionate Use of Protease Inhibitors in Viral C in Liver Transplantation Study Group. Efficacy of sofosbuvir and daclatasvir in patients with fibrosing cholestatic hepatitis C after liver transplantation. Clin Gastroenterol Hepatol. 2015;13:1993-2001.e1-2. (Among 23 patients with fibrosing cholestatic hepatitis C after liver transplantation treated with sofosbuvir and daclatasvir [n=15] or sofosbuvir and ribavirin [n=8] for 24 weeks, SVR was achieved in 22 [96%]; one patient developed worsening cholestasis after 12 weeks that did not improve when daclatsavir was stopped [16 weeks], but did when sofosbuvir was stopped [24 weeks]).
Collins JM, Raphael KL, Terry C, Cartwright EJ, Pillai A, Anania FA, Farley MM, Hepatitis B. (2015). Virus Reactivation During Successful Treatment of Hepatitis C Virus With Sofosbuvir and Simeprevir. Clin Infect Dis. (2 cases: 55 year old man with chronic hepatitis C, genotype 1, and HBsAg with low levels of HBV DNA [2300 IU/mL] developed jaundice 8 weeks after starting sofosbuvir and simeprevir [bilirubin 12.2 mg/dL, ALT 1495 U/L, INR 1.96, HBV DNA 22 million IU/mL], with resolution within 6 weeks of stopping HCV agents and starting tenofovir and emtricitabine [Case 2]; 57 year old man with chronic hepatitis C, genotype 1a, and anti-HBc without HBsAg developed rising levels of HBV DNA during therapy with sofosbuvir and simeprevir [Pre <20, 2 weeks 353 and 4 weeks 11,255 IU/mL], which fell to undetectable levels within 8 weeks of starting tenofovir with emtricitabine [Truvada], ALT values remaining normal during the episode).
Ferenci P, Kozbial K, Mandorfer M, Hofer H. (2015). HCV targeting of patients with cirrhosis. J Hepatol. (Review of the status of antiviral therapy of chronic hepatitis C with cirrhosis, suggests that genotype 1 infected patients should receive an all-oral regimen such as dual therapy with sofosbuvir and ledipasvir or daclatasvir or the triple combination of dasabuvir with ombitasvir and paritaprevir, the major unresolved issues being duration of therapy and the role of ribavirin).
Kalafateli M, Dusheiko G, Manousou P. (2015). Clinical decompensation after achieving SVR with sofosbuvir, daclatasvir and ribavirin in a patient with recurrent HCV post-liver transplant. J Gastrointestin Liver Dis. (33 year old male with hemophilia and chronic hepatitis C, genotype 3, underwent liver transplantation and had recurrence of HCV posttransplant, subsequently failing to respond to several interferon based courses of therapy, eventually responding to sofosbuvir, daclatasvir and ribavirin, but then developing hepatic decompensation 2 months after achieving an SVR).
Bailly F, Pradat P, Virlogeux V, Zoulim F. (2015). Antiviral therapy in patients with hepatitis C virus-induced cirrhosis. Dig Dis. (Review of the status of antiviral therapy of chronic hepatitis C with cirrhosis summarizing the high rate of adverse events, including hepatic decompensation and death with peginterferon based regimens combined with boceprevir or telaprevir and the more effective and better tolerated all oral regimens).
Wyles DL, Ruane PJ, Sulkowski MS, Dieterich D, Luetkemeyer A, Morgan TR, Sherman KE, et al. (2015). ALLY-2 Investigators. Daclatasvirr plus sofosbuvir for HCV in patients coinfected with HIV-1. N Engl J Med. (Among 203 patients with chronic hepatitis C, genotype 1 to 4, and HIV coinfection treated with sofosbuvir and daclatasvir for 8 or 12 weeks, SVR rates were 97% to 98% [12 weeks] and 76% [8 weeks] and there were no discontinuations for adverse events, treatment related serious adverse events or ALT elevations above 3 times ULN).
Ende AR, Kim NH, Yeh MM, Harper J, Landis CS. (2015). Fulminant hepatitis B reactivation leading to liver transplantation in a patient with chronic hepatitis C treated with simeprevir and sofosbuvir: a case report. J Med Case Rep. (59 year old woman with chronic hepatitis C, genotype 1, and anti-HBc without HBsAg or HBV DNA in serum, developed jaundice 11 weeks after starting sofosbuvir and simeprevir [bilirubin 9.1 mg/dL, ALT 2263 U/L, INR 1.9, HBV DNA 29 million IU/mL]; she was started on tenofovir, but developed progressive liver failure and underwent emergency liver transplantation 10 days after presentation).
Shibata S, Umemura T, Komatsu M, Tanaka E. (2016). Severe hepatotoxicity associated with asunaprevir and daclatasvir in chronic hepatitis C. Hepatology. (58 year old Japanese woman with chronic hepatitis C, genotype 1b, developed fever followed by dark urine 11 days after starting daclatasvir and asunaprevir [bilirubin 6.6 mg/dL, ALT 114 U/L, Alk P 253 U/L, eosinophils 20%], with severe course [ascites and coagulopathy], but eventual full recovery).
Renet S, Chaumais MC, Antonini T, Zhao A, Thomas L, Savoure A, Samuel D, et al. (2015). Extreme bradycardia after first doses of sofosbuvir and daclatasvir in patients receiving amiodarone: 2 cases including a rechallenge. Gastroenterology. (Two patients taking amiodarone developed severe bradycardia within 2 hours of receiving sofosbuvir and daclatasvir, one of whom had a positive rechallenge 13 days, but not 8 weeks after stopping amiodarone).
Kumada H, Suzuki F, Suzuki Y, Toyota J, Karino Y, Chayama K, Kawakami Y, et al. (2016). Randomized comparison of daclatasvir + asunaprevir versus telaprevir + peginterferon/ribavirin in Japanese HCV patients. J Gastroenterol Hepatol. (Among 252 patients with chronic hepatitis C, genotype 1, treated with daclatasvir and asunaprevir vs telaprevir and peginterferon with ribavirin, SVR rates were higher [89% vs 62%] and adverse event rates lower with the all oral regimen, but one patient discontinued therapy early because of ALT elevations above 5 times ULN, resolving on stopping and achieving an SVR; ALT elevations occurred in 17% of those receiving daclatasvir and asunaprevir and were above 5 times ULN in 11%).
Fujii Y, Uchida Y, Mochida S. (2016). Reply to the Letter Entitled "Severe Hepatotoxicity Associated with Asunaprevir and Daclatasvirr in Chronic Hepatitis C". Hepatology. (Letter in response to Shibata [2015] mentions that immunoallergic liver injury occurred in 9 of 297 patients treated with asunaprevir and daclatasvir with fever, CRP elevations or eosinophilia arising 4 to 20 weeks after starting therapy).
Fontana RJ, Brown RS, Moreno-Zamora A, Prieto M, Joshi S, Londoño MC, et al. (2016). Daclatasvir combined with sofosbuvir or simeprevir in liver transplant recipients with severe recurrent hepatitis C infection. Liver Transpl. (Among 97 liver transplant recipients treated with daclatasvir and either sofosbuvir or simeprevir with or without ribavirin for up to 24 weeks, 84 [87%] had a sustained response and 8 [8%] patients died, but none of the deaths were considered due to the antiviral therapy).
Suda G, Kudo M, Nagasaka A, Furuya K, Yamamoto Y, Kobayashi T, Shinada K, et al. (2016). Efficacy and safety of daclatasvir and asunaprevir combination therapy in chronic hemodialysis patients with chronic hepatitis C. J Gastroenterol. (Among 21 patients with chronic hepatitis C, genotype 1, and renal failure on hemodialysis who were treated with daclatasvir and asuneprevir for 24 weeks, 20 [96%] had a sustained response, including 1 patient who stopped treatment at week 12 because of ALT elevations 10 times ULN).
Poordad F, Schiff ER, Vierling JM, Landis C, Fontana RJ, Yang R, McPhee F, Hughes EA, Noviello S, Swenson ES. (2016). Daclatasvir With Sofosbuvir and Ribavirin for HCV Infection With Advanced Cirrhosis or Post-Liver Transplant Recurrence. Hepatology. (Among 60 patients with advanced cirrhosis and 53 transplant recipients with chronic hepatitis C who were treated with daclatasvir, sofosbuvir and ribavirin for 12 weeks, sustained response rates were 93% in Child-Pugh class A and B cirrhosis and 56% in class C, and 95% in transplant patients; " there were no treatment related serious adverse events").
Kao JH, Jensen DM, Manns MP, Jacobson I, Kumada H, Toyota J, Heo J, et al. (2016). Daclatasvir plus asunaprevir for HCV genotype 1b infection in patients with or without compensated cirrhosis: a pooled analysis. Liver Int. (In a pooled analysis of 4 clinical trials of daclatasvir and asunaprevir, sustained response rates were similar in those with and without cirrhosis [84%and 84%], serious adverse events were less common [1% vs 3%], and there were no deaths).
Jafri SM, Gordon SC. (2015). The safety of daclatasvir for the treatment of hepatitis C. Expert Opin Drug Saf. (Survey of the literature on safety of daclatasvir concludes that it is effective).
Hézode C, Alric L, Brown A, Hassanein T, Rizzetto M, Buti M, et al. (2015). COMMAND-4 study team. Randomized controlled trial of the NS5A inhibitor daclatasvir plus peginterferon and ribavirin for HCV genotype-4 (COMMAND-4). Antivir Ther. (Among 124 patients with chronic hepatitis C, genotype 4, treated with daclatsavir or placebo with peginterferon and ribavirin for 24 to 48 weeks, sustained response rates were 82% [with daclatasvir] and 43% [without] and there were no serious adverse events attributed to daclatasvir).
European Association for Study of Liver. (2015). EASL Recommendations on Treatment of Hepatitis C 2015. J Hepatol. (Guidelines for the antiviral therapy of chronic hepatitis C from the European liver disease research and academic society).
AASLD/IDSA HCV Guidance Panel. (2015). Hepatitis C guidance: AASLD-IDSA recommendations for testing, managing, and treating adults infected with hepatitis C virus. Hepatology. (Guidelines for the antiviral therapy of chronic hepatitis C from the US liver and infectious diseases research and academic societies).
(2015). Daclatasvir (Daklinza) for hepatitis C virus genotype 3. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of daclatasvir as therapy of hepatitis C, does not mention hepatotoxicity or ALT elevations).
Everson GT, Sims KD, Thuluvath PJ, Lawitz E, Hassanein T, Rodriguez-Torres M, et al. (2016). Daclatasvir + asunaprevir + beclabuvir ± ribavirin for chronic HCV genotype 1-infected treatment-naive patients. Liver Int. (Among 187 patients with chronic hepatitis C, genotype 1, who were treated with daclatasvir, asunaprevir, beclabuvir with or without ribavirin for 12 weeks, 169 [90%] had a sustained response, one patient had a transient elevation in ALT [114 U/L] and AST [295 U/L] without symptoms or jaundice, which resolved without dose modification).
Akuta N, Sezaki H, Suzuki F, Kawamura Y, Hosaka T, Kobayashi M, Kobayashi M, et al. (2016). Relationships between serum asunaprevir concentration and alanine aminotransferase elevation during daclatasvir plus asunaprevir for chronic HCV genotype 1b infection. J Med Virol. (Among 70 patients with chronic hepatitis C, genotype 1b, treated with daclatasvir and asunaprevir who had serum levels measured, ALT elevations were more frequent in those with higher serum levels of asunaprevir).
Dyson JK, Hutchinson J, Harrison L, Rotimi O, Tiniakos D, Foster GR, Aldersley MA, et al. (2016). Liver toxicity associated with sofosbuvir, an NS5A inhibitor and ribavirin use. J Hepatol. (36 year old woman with HCV related cirrhosis developed worsening hepatic decompensation within 3 weeks of starting sofosbuvir, daclatasvir and ribavirin [peak bilirubin 30.5 mg/dL, ALT 96 U/L, Alk P 398 U/L] and she continued to worsen after antiviral therapy was stopped, undergoing successful liver transplantation on day 37 after starting).
Marchan-Lopez A, Dominguez-Dominguez L, Kessler-Saiz P, Jarrin-Estupiñan ME. (2016). Liver failure in human immunodeficiency virus - hepatitis C virus coinfection treated with sofosbuvir, ledipasvir and antiretroviral therapy. J Hepatol. (Letter in response to Dyson [2016]: 49 year old man with chronic hepatitis C, cirrhosis [Child-Pugh class B] and HIV coinfection developed worsening hepatic decompensation 1 to 2 months after starting sofosbuvir and ledipasvir that worsened for two weeks after stopping [peak bilirubin 46.9 mg/dL, INR 3.17], and then resolved; he later tolerated reinitiation of antiretroviral drugs).
Dyson JK, McPherson S. (2016). Reply to "Liver failure in human immunodeficiency virus - Hepatitis C virus coinfection treated with sofosbuvir, ledipasvir and antiretroviral therapy". J Hepatol. (Letter in reply to March-Lopez [2016] reporting another case of hepatic decompensation during sofosbuvir, ledipasvir and ribavirin therapy of a patient hepatitis C, cirrhosis and HIV coinfection, arising within 6 weeks of starting treatment [bilirubin 12.6 mg/dL, protime 17 sec], and leading to successful, emergency liver transplantation).
Welker MW, Luhne S, Lange CM, Vermehren J, Farnik H, Herrmann E, Welzel T, et al. (2016). Lactic acidosis in patients with hepatitis C virus cirrhosis and combined ribavirin/ sofosbuvir treatment. J Hepatol. (Among 35 patients with chronic hepatitis C and advanced fibrosis or cirrhosis treated with sofosbuvir based regimens, 12 [34%] had a serious adverse event and 5 [14%] developed lactic acidosis, largely in those with Child-Pugh class B and C cirrhosis and in the context of hepatic decompensation, 2 of whom died).
Hoofnagle JH. (2016). Hepatic decompensation during direct-acting antiviral therapy of chronic hepatitis C. J Hepatol. (Editorial in response to Welker [2016] discussing the occurrence of unexplained hepatic decompensation during antiviral therapy of hepatitis C and whether these episodes are coincidental, caused by hepatoxicity of the antiviral drugs, or are the paradoxical result of sudden eradication of the chronic viral infection).
Miyashima Y, Honma Y, Miyagawa K, Oe S, Senju M, Shibata M, Hiura M, et al. (2016). Daclatasvir and asunaprevir combination therapy-induced hepatitis and cholecystitis with coagulation disorder due to hypersensitivity reactions. Intern Med. (70 year old woman developed skin rash, fever and abdominal tenderness with minimal change in bilirubin and serum enzymes 2 weeks after starting daclatasvir and asunaprevir for chronic hepatitis C [bilirubin 1.1 mg/dL, ALT 102 U/L, Alk P 220 U/L, eosinophils 13%], resolving within 6 weeks of stopping).
Morio K, Imamura M, Kawakami Y, Morio R, Kobayashi T, Yokoyama S, Nagaoki Y, et al. (2017). Real-world efficacy and safety of daclatasvir and asunaprevir therapy for hepatitis C virus-infected cirrhosis patients. J Gastroenterol Hepatol. (Among 252 Japanese patients with chronic hepatitis C treated with daclatasvir and asunaprevir for 24 weeks, the SVR rate was 93%, ALT elevations above 3 times ULN occurred in 17 [7%; discontinuation because of ALT elevations in 2 [1%] and liver decompensation in 1).
Benítez-Gutiérrez L, de Mendoza C, Baños I, Duca A, Arias A, Treviño A, Requena S, et al. (2016). Drug-induced lung injury in a liver transplant patient treated With sofosbuvir. Transplant Proc. (Among 24 liver transplant recipients with chronic hepatitis C treated with sofosbuvir containing antiviral regimens, 23 [95%] achieved an SVR, but one developed severe respiratory failure [suspected drug induced lung injury] 10 days after starting therapy, which was successfully treated with prednisone and she was later was successfully treated with 24 weeks of daclatasvir and simeprevir and achieved an SVR).
Suda G, Nagasaka A, Yamamoto Y, Furuya K, Kumagai K, Kudo M, Terashita K, et al., NORTE Study Group. (2017). Safety and efficacy of daclatasvir and asunaprevir in hepatitis C virus-infected patients with renal impairment. Hepatol Res. (Among 322 patients with renal dysfunction and chronic hepatitis C treated with daclatasvir and asunaprevir for 24 weeks, 289 [90%] achieved an SVR, 17 [5%] had ALT elevations above 3 times ULN, of whom 8 discontinued therapy early, 7 of whom achieved an SVR and no patient developed clinically apparent liver injury).
Suda G, Kudo M, Nagasaka A, Furuya K, Yamamoto Y, Kobayashi T, Shinada K, et al. (2016). Efficacy and safety of daclatasvir and asunaprevir combination therapy in chronic hemodialysis patients with chronic hepatitis C. J Gastroenterol. (Among 21 patients with chronic hepatitis C and renal failure on hemodialysis treated with daclatasvir and asunaprevir for 24 weeks, 20 [95%] had an SVR and 3 [14%] had ALT elevations above 5 times ULN, one of whom discontinued therapy early, but still achieved an SVR).
Pol S, Bourliere M, Lucier S, Hezode C, Dorival C, Larrey D, Bronowicki JP, et al., ANRS/AFEF HEPATHER study group. (2017). Safety and efficacy of daclatasvir-sofosbuvir in HCV genotype 1-mono-infected patients. J Hepatol. (Among 798 patients with chronic hepatitis C, genotype 1, [80% with cirrhosis] treated with sofosbuvir and daclatasvir with or without ribavirin for 12 or 24 weeks, the overall SVR rate was 95%, cirrhotic patients having a higher SVR rate with 24 than 12 weeks [96% vs 92%]; two patients with cirrhosis died of end-stage liver disease at 11 and 24 weeks of treatment).
Lawitz E, Poordad F, Gutierrez JA, Kakuda TN, Picchio G, Beets G, Vandevoorde A, et al. (2017). Simeprevir, daclatasvir and sofosbuvir for hepatitis C virus-infected patients with decompensated liver disease. J Viral Hepat. (Among 40 patients with chronic hepatitis C, genotype 1 or 4, and cirrhosis treated with sofosbuvir, simeprevir and daclatasvir for 12 weeks, all patients achieved an SVR and while 2 patients had an episode of decompensation on treatment and Child’s Pugh scores worsened in 7 patients, there were no deaths and no early discontinuations).
Hézode C, Almasio PL, Bourgeois S, Buggisch P, Brown A, Diago M, Horsmans Y, et al. (2017). Simeprevir and daclatasvir for 12 or 24 weeks in treatment-naïve patients with hepatitis C virus genotype 1b and advanced liver disease. Liver Int. (Among 106 adults with chronic hepatitis C, genotype 1, and advanced liver disease treated with simeprevir and daclatasvir for 12 or 24 weeks, the overall SVR rate was 92% with both 12 and 24 weeks of treatment, 70% had adverse events, 6% serious adverse events but there was only one severe liver related event, a transient and asymptomatic rise in ALT and AST levels above 5 times ULN).
Hézode C, Lebray P, De Ledinghen V, Zoulim F, Di Martino V, Boyer N, Larrey D, et al. (2017). Daclatasvir plus sofosbuvir, with or without ribavirin, for hepatitis C virus genotype 3 in a French early access programme. Liver Int. (Among 333 adults with chronic hepatitis C, genotype 3, [cirrhosis in 77%] treated with sofosbuvir and daclatasvir for 24 weeks, the overall SVR rate was 89%, and was 88% in those with and 98% in those without cirrhosis, while the adverse event rate was 37%, serious adverse event rate 14%, 3 patients developed decompensation during treatment and one died of liver failure).
Saxena V, Khungar V, Verna EC, Levitsky J, Brown RS, Hassan MA, Sulkowski MS, et al. (2017). Safety and efficacy of current direct-acting antiviral regimens in kidney and liver transplant recipients with hepatitis C: Results from the HCV-TARGET study. Hepatology. (Among 412 patients with liver or kidney transplants or both and chronic hepatitis C treated with direct acting antiviral agents with or without ribavirin in a prospective observational study, the SVR rate was 96% with sofosbuvir and ledipasvir and somewhat lower with sofosbuvir and daclatasvir and Viekira Pak; serious adverse events occurred in 10%, including hepatic encephalopathy in 2 patients).
El-Khayat H, Fouad Y, Mohamed HI, El-Amin H, Kamal EM, Maher M, Risk A. (2018). Sofosbuvir plus daclatasvir with or without ribavirin in 551 patients with hepatitis C-related cirrhosis, genotype 4. Aliment Pharmacol Ther. (Among 551 Egyptian adults with chronic hepatitis C, genotype 4, with cirrhosis treated with sofosbuvir and daclatasvir with ribavirin for 12 weeks and without ribavirin for 24 weeks, the SVR rate was 92% and serious adverse events arose mostly in those with decompensated cirrhosis, which included hepatic encephalopathy and liver cancer).
Kwo P, Fried MW, Reddy KR, Soldevila-Pico C, Khemichian S, Darling J, Zamor PJ, et al. (2018). Daclatasvir and sofosbuvir treatment of decompensated liver disease or post-liver transplant hepatitis C virus recurrence in patients with advanced liver disease/cirrhosis in a real-world cohort. Hepatol Commun. (Among 77 patients with chronic hepatitis C with decompensated cirrhosis [n=14] or recurrent hepatitis C after liver transplant treated with sofosbuvir and daclatasvir with or without ribavirin for 24 weeks, the SVR rate was 62% for those with decompensated cirrhosis and 90% with recurrence after transplantation; adverse events were reported in 90% of patients which were serious in 39%, leading to discontinuation of therapy in 13% and resulting in death in 6 [4 were liver related]).
Sulkowski MS, Feld JJ, Lawitz E, Felizarta F, Corregidor AM, Khalid O, Ghalibv R, et al. (2018). Efficacy and safety of 6 or 8 weeks of simeprevir, daclatasvir, sofosbuvir for HCV genotype 1 infection. J Viral Hepat. (Among 68 adults with chronic hepatitis C, genotype 1, treated with simeprevir, daclatasvir and sofosbuvir for either 6 weeks [mild fibrosis] or 8 weeks [cirrhosis], the SVR rate was 86% in the 6 week and 100% in the 8 week arm, but relapse was frequent [12%]; there were no therapy related serious adverse events or elevations of serum ALT above 5 times ULN).
Shiha G, Soliman R, ElBasiony M, Hassan AA, Mikhail NNH. (2018). Sofosbuvir plus daclatasvir with or without ribavirin for treatment of chronic HCV genotype 4 patients: real-life experience. Hepatol Int. (Among 1168 Egyptian adults with chronic hepatitis C, genotype 4, treated with sofosbuvir and daclatasvir with or without ribavirin for 12 or 24 weeks, the SVR rate was 97% and there were no serious adverse events and only one patient discontinued therapy early for side effects).
Miotto N, Mendes LC, Zanaga LP, Lazarini MSK, Goncales ESL, Pedro MN, Goncales FL, Stucchi RSB, et al. (2018). All-oral direct antiviral treatment for hepatitis C chronic infection in a real-life cohort: The role of cirrhosis and comorbidities in treatment response. PLoS One. (Among 527 Brazilian patients with chronic hepatitis C treated with interferon free regimens [including sofosbuvir, daclatasvir, ribavirin and simeprevir] between 2015 and 2018, the overall SVR rate was 91% and 22 of 272 patients [8%] with cirrhosis had decompensation during therapy).
Cheng PN, Chiu YC, Chien SC, Chiu HC. (2019). Real-world effectiveness and safety of sofosbuvir plus daclatasvir with or without ribavirin for genotype 2 chronic hepatitis C in Taiwan. J Formos Med Assoc. (Among 32 Taiwanese adults with chronic hepatitis C, genotype 2, [50% with cirrhosis, decompensated in 19%] treated with sofosbuvir and daclatasvir for 12 weeks, the SVR rate was 100%; 1 patient had a transient ALT elevation above 5 times ULN, and severe adverse events included a death from heart failure in one patient and transient hepatic encephalopathy in another).
Poordad F, Shiffman ML, Ghesquiere W, Wong A, Huhn GD, Wong F, Ramji A, et al. (2019). ALLY-3C study team. Daclatasvir and sofosbuvir with ribavirin for 24 weeks in chronic hepatitis C genotype-3-infected patients with cirrhosis: a Phase III study (ALLY-3C). Antivir Ther. (Among 78 patients with chronic hepatitis C, genotype 3, with compensated cirrhosis treated with sofosbuvir and daclatasvir without ribavirin for 24 weeks, the SVR rate was 87% and there were no deaths, but 8 serious adverse events, but none were liver related).
Pariente A, Arpurt JP, Rémy AJ, Rosa-Hézode I, Causse X, Heluwaert F, Macaigne G, et al. (2019). Association nationale des gastroentérologues des hôpitaux (ANGH). Hepatitis C treatment with all-oral direct-acting antivirals: Effectiveness and tolerance in a multicenter, prospective, observational study from French general hospitals (APROVVIE, ANGH). Presse Med. (Among 1123 patients with chronic hepatitis C treated at 24 French general hospitals with various interferon-free antiviral regimens for 12 or 24 weeks the overall response rate was 91% with lower responses among 553 patients with cirrhosis, two of whom developed hepatic decompensation and died).
Wahid B. (2019). Hepatotoxicity and virological breakthrough of HCV following treatment with sofosbuvir, daclatasvir, and ribavirin in patients previously treated for tuberculosis. J Med Virol. (A 71 year old man with chronic hepatitis C and decompensated cirrhosis being treated with sofosbuvir, daclatasvir and ribavirin developed virologic breakthrough and worsening ascites after 3 months of therapy).
El Kassas M, Abdeen N, Omran D, Alboraie M, Salaheldin M, Eltabbakh M, Farghaly R, et al. Safety and efficacy of sofosbuvir/ledipasvir and sofosbuvir/daclatasvir in the treatment of hepatitis C in patients with decompensated cirrhosis. Eur J Gastroenterol Hepatol. 2021;33(1S Suppl 1):e877-e882. (Among 145 Egyptian patients with chronic hepatitis C and decompensated cirrhosis treated with sofosbuvir combined with ledipasvir or daclatasvir, the SVR rate was 88% and 11 patients had to discontinue therapy easy because of ALT elevations or worsening decompensation).

## OTHER REFERENCE LINKS

1 Recent References on Daclatasvir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Daclatasvir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Daclatasvir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Daclatasvir)